# Ocrelizumab

## OVERVIEW

### Introduction

Ocrelizumab is a humanized monoclonal antibody to CD20 which is used as therapy of multiple sclerosis. Ocrelizumab is associated with a low rate serum enzyme elevations during therapy and to rare instances of clinically apparent liver injury and to reactivation of hepatitis B in susceptible patients which is usually mild but can be severe.

### Background

Ocrelizumab (ok" re liz' ue mab) is a humanized IgG1 monoclonal antibody to CD20, a cell surface antigen found on pre-B cells, mature B cells and memory B cells. Engagement of CD20 causes cell lysis resulting in B cell depletion which may be beneficial in autoimmune conditions mediated by autoantibodies. Ocrelizumab like rituximab is directed against CD20 but has a broader reactivity and is a humanized monoclonal, unlike rituximab that is a mouse-human chimeric molecule. Ocrelizumab was found to be beneficial in multiple sclerosis, decreasing rates of relapse as well as slowing progression. Ocrelizumab was approved for use in the United States in 2017 for both progressive and relapsing multiple sclerosis. Ocrelizumab is under evaluation in other autoimmune and malignant conditions but is not approved for these uses. Ocrelizumab is available in liquid solution in single use vials of 300 mg (30 mg/mL) under the brand name Ocrevus. The recommended dose is 600 mg intravenously every 6 months, the initial dose being given as two separate infusions of 300 mg 2 weeks apart. Pretreatment with corticosteroids and antihistamines is recommended with each infusion. Treatment results in a rapid decline in circulating B cells and decrease in immunoglobulin levels, effects that persist for 6 to 18 months. Common adverse events include infusion reactions, cough, diarrhea, skin rash and infections, particularly herpes simplex. Rare but potentially serious adverse events include reactivation of hepatitis B, severe viral infections, increased risk of malignancy, and progressive multifocal leukoencephalopathy (PML).

### Hepatotoxicity

Mild-to-moderate serum aminotransferase elevations were reported to occur in 1% to 2% of patients during ocrelizumab therapy. The elevations, however, were self-limited and resolved even with continuing cyclic therapy and were no more frequent than occurred with placebo. During premarketing evaluation of ocrelizumab, clinically apparent, acute liver injury with symptoms or jaundice were not reported, but fewer than 2 thousand patients had received the agent. Since its approval and more wide-scale use, ocrelizumab has been implicated in a small number of cases. The injury arose within a few weeks to several months after the initial infusion and was typically hepatocellular. Some cases were severe and fatalities have been reported. The reported cases often arose in patients who received other potential hepatotoxic medications most frequent high-dose methylprednisolone, which can also cause acute hepatocellular injury with or without jaundice. The clinical presentation of injury resembles an immune mediated injury and is often treated with corticosteroids and further immune suppression which can result in complications in these patients with B cell depletion from the ocrelizumab therapy.

Monoclonal antibodies against CD20 similar to ocrelizumab such as rituximab and ofatumumab have been implicated in cases of reactivation of hepatitis B some of which have been severe and even fatal. HBV reactivation typically occurs in patients with preexisting HBsAg and relatively inactive disease, but in some instances, it occurs in patients with anti-HBc without HBsAg. Reactivation causes acute hepatocellular injury that can be severe and lead to acute liver failure and death or need for emergency liver transplantation. Since the approval and more widespread use of ocrelizumab, isolated instances of reactivation of hepatitis B have been reported, both in patients with preexisting HBsAg in serum (HBsAg carriers) and those with anti-HBc without HBsAg (serologic pattern associated with recovery from HBV infection). For these reasons, patients who are to receive ocrelizumab should be screened for HBsAg and anti-HBc before starting therapy. Those with markers of HBV infection should either be given prophylaxis against (using oral antiviral agents with activity against HBV) or monitored carefully for HBV DNA in serum and initiated on antiviral therapy if levels become detectable or rise significantly.

Likelihood score: C (rare cause of clinically apparent liver injury, sometimes due to reactivation of hepatitis B).

### Mechanism of Liver Injury

The mechanism of liver injury in reactivation of hepatitis B appears to be a brisk immunological response to newly expressed viral antigens following profound immune suppression and gradual recovery. Injury generally arises between courses of monoclonal anti-CD20 therapy and may be delayed. The hepatocellular injury that has been reported with ocrelizumab therapy is probably idiosyncratic but may also result from other drugs used for multiple sclerosis that are capable of causing liver injury.

### Outcome and Management

Guidelines for management of patients who are to receive ocrelizumab recommend routine screening for hepatitis B before starting treatment. Screening should include tests for HBsAg and anti-HBc (and perhaps also anti-HBs as this may help in management). Prophylaxis with a potent oral, antiviral agent effective against hepatitis B is recommended for persons who have HBsAg in serum and is suggested for those with anti-HBc without HBsAg. An alternative approach which is perhaps more appropriate for ocrelizumab is careful monitoring for HBV DNA during therapy and early institution of antiviral therapy if levels rise. At present, hepatitis B is considered a relative contraindication to the use of ocrelizumab in multiple sclerosis.

Drug Class: Multiple Sclerosis Agents; Monoclonal Antibodies

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Ocrelizumab – Ocrevus®

DRUG CLASS

Multiple Sclerosis Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Ocrelizumab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Ocrelizumab | 637334-45-3 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 30 September 2025

Abbreviations Used: HBV, hepatitis B virus; anti-HBc, antibody to hepatitis B core antigen; anti-HBs, antibody to hepatitis B surface antigen.

Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 569-91. (Review of hepatotoxicity of immunosuppressive agents; does not mention ocrelizumab specifically but discussed the problems of reactivation of hepatitis B and states that "the biological immunosuppressants are largely free from hepatotoxicity, with the exception of the TNF alpha antagonists").
Krensky AM, Azzi JR, Hafler DA. Immunotherapy for multiple sclerosis. Immunosuppressants and tolerogens. In, Brunton LL, Hilal-Dandan, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 649-652. (Textbook of pharmacology and therapeutics). https://www.accessdata.fda.gov/drugsatfda_docs/nda/2017/761053Orig1s000TOC.cfm (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy mentions little concerning hepatic adverse events).
Stohl W, Gomez-Reino J, Olech E, Dudler J, Fleischmann RM, Zerbini CA, Ashrafzadeh A, et al. Safety and efficacy of ocrelizumab in combination with methotrexate in MTX-naive subjects with rheumatoid arthritis: the phase III FILM trial. Ann Rheum Dis 2012; 71: 1289-96. 22307942 (Among 613 patients with rheumatoid arthritis treated with methotrexate with or without ocrelizumab [200 or 500 mg] for 52 weeks, clinical improvement was greater in the high dose group while adverse event rates were similar except for a high rate of serious infections that led to early discontinuation of the study; no mention of ALT elevations or hepatotoxicity, while none of 67 patients with anti-HBc developed evidence of HBV reactivation).
Mysler EF, Spindler AJ, Guzman R, Bijl M, Jayne D, Furie RA, Houssiau FA, et al. Efficacy and safety of ocrelizumab in active proliferative lupus nephritis: results from a randomized, double-blind, phase III study. Arthritis Rheum 2013; 65: 2368-79. 23740801 (Among 378 patients with lupus nephritis treated with ocrelizumab [400 and 1000 mg doses] vs placebo for 48 weeks, overall renal response rates were minimally higher with ocrelizumab; no mention of ALT elevations or hepatotoxicity).
Emery P, Rigby W, Tak PP, Dörner T, Olech E, Martin C, Millar L, et al. Safety with ocrelizumab in rheumatoid arthritis: results from the ocrelizumab phase III program. PLoS One 2014; 9: e87379. 24498318 (Among 2759 patients with rheumatoid arthritis treated with ocrelizumab [400 or 1000 mg] or placebo at baseline and 24 weeks, detailed safety analysis showed similar adverse events except for higher rates of serious infections with ocrelizumab, including one case of reactivation of HBV in patient who was initially anti-HBc positive but HBsAg and HBV DNA negative; “approximately 300 patients with this serologic status” were enrolled but no other cases of HBV reactivation were observed).
Montalban X, Hauser SL, Kappos L, Arnold DL, Bar-Or A, Comi G, de Seze J, et al.; ORATORIO Clinical Investigators. Ocrelizumab versus placebo in primary progressive multiple sclerosis. N Engl J Med 2017; 376: 209-20. 28002688 (Among 732 patients with progressive multiple sclerosis treated with ocrelizumab vs placebo, progression in disability over 12 weeks was less with ocrelizumab [33% vs 39%] while side effects that were more common with ocrelizumab were infusion reactions [40% vs 26%], upper respiratory infections [11% vs 6%], oral herpes [2.3% vs 0.9%] and neoplasms [2.3% vs 0.8%]; no mention of ALT elevations or hepatotoxicity).
Hauser SL, Bar-Or A, Comi G, Giovannoni G, Hartung HP, Hemmer B, Lublin F, et al.; OPERA I and OPERA II Clinical Investigators. Ocrelizumab versus interferon beta-1a in relapsing multiple sclerosis. N Engl J Med 2017; 376: 221-34. 28002679 (Among 1646 patients with relapsing multiple sclerosis treated with ocrelizumab vs interferon beta for 96 weeks in two clinical trials, relapse rates were 46-47% lower in ocrelizumab treated groups while overall and serious adverse event rates were similar including serious infections and herpes simplex; no mention of ALT elevations or hepatotoxicity).
Hauser SL, Belachew S, Kappos L. Ocrelizumab in primary progressive and relapsing multiple sclerosis. N Engl J Med 2017; 376: 1694. 28445661 (In a reply to a letter to the editor concerning Montalan [2017] and Hauser [2017], the authors explain that patients with HBsAg or anti-HBc with HBV DNA in serum were excluded from enrollment and those with anti-HBc alone were screened for HBV DNA at 12 week intervals, but do not mention whether instances of reactivation occurred).
Frampton JE. Ocrelizumab: first global approval. Drugs 2017; 77: 1035-41. 28523586 (Review of the development, mechanism of action, pharmacology, clinical efficacy and safety of ocrelizumab as therapy of multiple sclerosis, including a discussion of common adverse events such as infusion reactions and laboratory abnormalities of IgG, IgA and IgM and immunogenicity and serious adverse events such as infections and possibility of increased risk of malignancies, but does not mention ALT elevations, hepatotoxicity or reactivation of hepatitis B).
Ocrelizumab (Ocrevus) for MS. Med Lett Drugs Ther 2017; 59 (1523): 98-101. 28609424 (Concise review of the standard therapy of multiple sclerosis and the mechanism of action, clinical efficacy, safety and costs of ocrelizumab shortly after its approval in the US mentions that agents with similar mechanism of action can cause reactivation of HBV).
Ciardi MR, Iannetta M, Zingaropoli MA, Salpini R, Aragri M, Annecca R, Pontecorvo S, et al. Reactivation of hepatitis B virus with immune-escape mutations after ocrelizumab treatment for multiple sclerosis. Open Forum Infect Dis 2018; 6(1): ofy356. 30697576 (60 year old man with MS and anti-HBc without HBsAg or HBV DNA in serum developed mild and asymptomatic reactivation of HBV 6 weeks after starting ocrelizumab [HBV DNA rising from undetectable to 184 IU/mL, ALT normal, HBsAg negative], HBV DNA returning to negative upon starting entecavir).
Nicolini LA, Canepa P, Caligiuri P, Mikulska M, Novi G, Viscoli C, Uccelli A. Fulminant hepatitis associated with echovirus 25 during treatment with ocrelizumab for multiple sclerosis. JAMA Neurol 2019; 76: 866-7. 30958517 (44 year old woman with MS developed fever, diarrhea and rash followed by severe hepatitis [bilirubin initially normal and rising to 4 mg/dL, ALT 6241 U/L, INR 2.95, HBsAg and HBV DNA negative] leading to emergency liver transplantation, serum later found to harbor enterovirus 25 RNA).
Antonazzo IC, Poluzzi E, Forcesi E, Riise T, Bjornevik K, Baldin E, Muratori L, et al. Liver injury with drugs used for multiple sclerosis: a contemporary analysis of the FDA Adverse Event Reporting System. Mult Scler. 2019;25:1633-1640. PIMD: 30230957. (Among 4873 cases of severe liver injury attributed to agents used to treat multiple sclerosis reported to the FDA’s Adverse Event Reporting System between 2004 and 2016, the most frequently implicated agents were interferon-beta 1a [n=2343], natalizumab [n=759], interferon beta 1b [535], fingolimod [496], dimethyl fumarate [223], glatimer acetate [212] and teriflunomide [158], no mention of ocrelizumab which was approved after 2016).
Biolato M, Bianco A, Lucchini M, Gasbarrini A, Mirabella M, Grieco A. The disease-modifying therapies of relapsing-remitting multiple sclerosis and liver injury: a narrative review. CNS Drugs. 2021;35:861-880.. (Extensive review of the frequency and characteristics of hepatic injury associated with different disease modifying drugs for multiple sclerosis, mentions that elevations in serum aminotransferase levels arise in 5% of treated patients but are generally transient and mild, but that rare instances of acute liver injury with autoimmune features have been reported). 34319570
Ng HS, Zhu F, Zhao Y, Yao S, Lu X, Ekuma O, Evans C, Fisk JD, Marrie RA, Tremlett H. Adverse Events associated with disease-modifying drugs for multiple sclerosis: a multiregional population-based study. Neurology. 2024;102:e208006.. (Among 35,894 people from 4 Canadian provinces with multiple sclerosis and available health data there was an increased risk for incident chronic liver disease in patients on teriflunomide and acute liver injury in those on dimethyl fumarate, no mention of ocrelizumab). 38181306
McEntire CRS, Lesser CF, Venna N. Case report and clinical reasoning: fulminant liver failure and invasive aspergillosis following ocrelizumab treatment in a 21 year-old woman. Neurohospitalist. 2023;13:96-102.. (21 year old woman with multiple sclerosis developed fatigue and jaundice 2 weeks after an initial infusion of ocrelizumab and 8 weeks after 5 days of high dose iv methylprednisolone [bilirubin 27.6 mg/dL, ALT 1086 U/L, Alk P not given, INR 4.8] which improved with corticosteroid therapy but she later developed weakness and neurologic deterioration due to bacterial and fungal infection that ultimately led to her death [final bilirubin 2.5 mg/dL, ALT 54 U/L, INR 1.1]). 36531849
Marzo B, Vidal-Jordana A, Castilló J, Robles-Sanchez MA, Otero-Romero S, Tintore M, Montalban X, et al. Hepatitis B reactivation is a rare event among patients with resolved infection undergoing anti-CD20 antibodies in monotherapy without antiviral prophylaxis: results from the HEBEM study. J Neurol. 2024;271:134-140.. (Among 540 adults initiating iv therapy with monoclonal antibody to CD20 for multiple sclerosis or neuromyelitis optica spectrum disorder, 28 tested positive for anti-HBc without HBsAg or HBV DNA [21 had anti-HBs] none developed evidence of reactivation during a median of 3 years of monitoring for HBV DNA or HBsAg including 6 receiving ocrelizumab and 22 rituximab). 37695530
Mariottini A, Barilaro A, Lotti A, Marra F, Massacesi L. Successful switch to ofatumumab after liver injury associated with ocrelizumab treatment in multiple sclerosis: a case report. Front Neurol. 2024;15:1363493.. (57 year old woman with muscular sclerosis who had liver injury after interferon beta, methylprednisolone, and glatiramer therapy, developed ALT elevations within 6 days of a first infusion of ocrelizumab and symptoms of liver injury one week after the second infusion [bilirubin 4.5 mg/dL, ALT 1198 U/L, Alk P 236 U/L] which resolved spontaneously within 2 months and she later tolerated ofatumumab without recurrence). 38487332
Challa B, Esnakula AK. Histologic manifestations of ocrelizumab-associated intestinal and hepatic injury in patients with multiple sclerosis. Histopathology. 2024;84:765-775.. (55 year old woman with multiple sclerosis developed liver injury 14 days after an initial infusion of ocrelizumab [peak bilirubin 12.7 mg/dL, ALT 2081 U/L, Alk P 173 U/L] with eventual resolution after prednisone and azathioprine therapy that was later discontinued without recurrence). 38114289
Erdogan T, Cansu C, Kocer B, Akkaya S, Kokmen H. Real-world effectiveness, safety and immunogenicity of ocrelizumab in Turkish multiple sclerosis patients: a single-center experience for 4-year follow-up. Acta Neurol Belg. 2024;124:1385-1391.. (Among 96 adults with multiple sclerosis treated with at least 2 doses of ocrelizumab at a single Turkish referral center, 94% remained normal in 94% of patients and there were no instances of HBV or tuberculosis reactivation; no mention of drug-induced liver injury). 38769274
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102.. (Among 483 cases of drug-induced liver injury enrolled in a prospective Latin American database, one case was attributed to fingolimod and one to natalizumab, but no other agents used to treat multiple sclerosis were listed: personal communication). 38992407

## OTHER REFERENCE LINKS

1. Recent References on Ocrelizumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Ocrelizumab/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Ocrelizumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Ocrelizumab)